# Cytotoxic Antibiotics

## OVERVIEW

Several naturally occurring compounds with antibiotic activity also have potent antitumor activity and were developed as anticancer agents. These cytotoxic antibiotics are often grouped together, even though they have diverse mechanisms of action, widely different indications, a range of efficacies and distinctive toxicities. The cytotoxic antibiotics in current use in the United States include (with trade name and year of approval): bleomycin (Blenoxane, 1973), dactinomycin (Cosmegen, 1964), daunorubicin (Cerubidine, 1979), doxorubicin (Adriamycin, 1974), epirubicin (Ellence, 1999), idarubicin (Idamycin, 1990), plicamycin (previously known as mithramycin, still experimental), mitomycin (Mutamycin, 2002) and mitoxantrone (Novantrone, 1987). A discussion of the mechanism of action, current use and hepatotoxicity, along with structural information and references of these drugs, are provided for each agent individually. The anthracycline antibiotics include daunorubicin, doxorubicin, epirubicin and idarubicin (which are discussed together) and mitoxantrone, which is an anthracycline analog and discussed separately.

Most of the cytotoxic antibiotics used in cancer chemotherapy have been implicated in cases of drug induced liver injury, generally associated with the use of high doses and with either direct hepatocellular injury or sinusoidal obstruction syndrome (from direct sinusoid cell injury). Because they are typically used in combination with other antineoplastic agents, it is often difficult to identify which is responsible for the liver injury.

Drug Class: Antineoplastic Agents

The cytotoxic antibiotics discussed in LiverTox include:

- Bleomycin
- Dactinomycin
- Daunorubicin
- Doxorubicin
- Epirubicin
- Idarubicin
- Mitomycin
- Mitoxantrone
- Plicamycin
- Valrubicin